# Triprolidine

## OVERVIEW

### Introduction

Triprolidine is a first generation antihistamine that is used for symptoms of allergic rhinitis and the common cold and as a short acting sedative. Triprolidine has not been linked to instances of clinically apparent acute liver injury.

### Background

Triprolidine (trye proe' li deen) is a first generation antihistamine that is used to treat the symptoms of the common cold, including sneezing, cough, runny note, watery eyes and itching. Triprolidine belongs to the ethanolamine class of antihistamines (with clemastine and dimenhydrinate) and is currently used largely in combination with pseudoephedrine in prescription or over-the-counter products for relief of symptoms of the common cold and allergic rhinitis. Representative brand names of products that include triprolidine include Aprodine and Silafed. The typical adult oral dose is 2.5 mg 3 to 4 times a day. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Like most first generation antihistamines, triprolidine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate its use in low dose for short periods only.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triprolidine – Generic (in combination), Aprodine®, Silafed®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Triprolidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Triprolidine | 486-12-4 | C19-H22-N2 | Triprolidine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Triprolidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Triprolidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Triprolidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triprolidine)